# Diclofenac

## OVERVIEW

### Introduction

Diclofenac is a commonly used nonsteroidal antiinflammatory drug (NSAID) used for the therapy of chronic forms of arthritis and mild-to-moderate acute pain. Therapy with diclofenac in full doses is frequently associated with mild serum aminotransferase elevations and, in rare instances, can lead to serious clinically apparent, acute or chronic liver disease.

### Background

Diclofenac (dye kloe' fen ak) is a phenylacetic acid derivative and belongs to the acetic acid class of NSAIDs that includes indomethacin, etodolac, ketorolac, nabumetone, tolmetin and sulindac. Like other NSAIDs, diclofenac acts as by inhibiting cellular cyclooxygenases (Cox-1 and Cox-2), which results in a decrease in production of pro-inflammatory prostaglandin, prostacyclin and thromboxane products, important mediators of inflammation and pain. Diclofenac has analgesic as well as antipyretic and antiinflammatory activities. Diclofenac was first approved in the United States in 1988 and currently over 5 million prescriptions are filled yearly. Current indications include mild-to-moderate forms of joint pain, caused by osteoarthritis, rheumatoid arthritis and ankylosing spondylitis as well as relief of symptoms of dysmenorrhea and mild-to-moderate pain. Diclofenac is available in multiple generic and brand formulations, either alone or in combination with other analgesics or gastrointestinal mucosal protective agents (such as misoprostol). Diclofenac is not available over-the-counter in the United States, but it is in many other countries where indications include joint and muscle pain from trauma, bursitis, tendonitis, headache and dysmenorrhea. As a result, diclofenac is one of the most frequently used NSAIDs worldwide. Common commercial names for agents containing diclofenac include: Arthrotec, Cataflam, Duravolten, Novo-Difenac, Nu-Diclo, Voltaren and Zorvoflex. Diclofenac is available in multiple dose formulations, including 25, 50 and 75 mg tablets or capsules. The recommended dose for chronic arthritis in adults is 50 mg orally three times daily; lower and intermittent doses are used for pain. Like most NSAIDs, diclofenac is generally well tolerated, but side effects can include headache, dizziness, somnolence, rash, nausea, diarrhea, dyspepsia, abdominal pain, heartburn, gastrointestinal bleeding, peripheral edema and hypersensitivity reactions.

Diclofenac is also available in several topical forms. Ophthalmic solutions (0.1%) are available for relief of pain or decrease in inflammation after cataract or corneal surgery. Dermatological gels are used for treatment of actinic keratoses. Diclofenac dermatologic patches are available for treatment of acute pain from minor strains, sprains and contusions. Diclofenac gels and creams have also been used for topical therapy of osteoarthritis for specific joints that are amenable to topical treatment. Topical formulations are available generically and under brand names such as Flector patch, Pennsaid, Solaraze, Surpass and Voltaren gel.

### Hepatotoxicity

Elevated serum aminotransferase levels have been reported in up to 15% of patients taking oral diclofenac chronically, but are greater than 3 times the upper limit of normal in only 2% to 4% (Cases 1 and 2). Clinically apparent and symptomatic liver disease with jaundice due to diclofenac is rare (1 to 5 cases per 100,000 prescriptions, occurring in 1 to 5 persons per 10,000 exposed). Nevertheless, more than a hundred instances of clinically apparent liver injury due to diclofenac have been reported in the literature and, in most case series, diclofenac ranks in the top 10 causes of drug induced liver injury. The time to onset of liver injury varies from within a week to over a year after starting. The majority of cases present within 2 to 6 months (Cases 3 and 4), and the more severe cases tend to present earlier. The pattern of injury is almost exclusively hepatocellular, although cases presenting with mixed patterns have been reported. The clinical picture is that of jaundice preceded by anorexia, nausea, vomiting and malaise. Fever and rash occur in 25% of cases and some cases have immunoallergic features, while others resemble chronic hepatitis and have autoimmune features. In most cases, liver histology reveals an acute lobular hepatitis. However, a cases with prolonged latency diclofenac hepatotoxicity can have clinical and histologic features of chronic hepatitis (Case 2). There seems to be greater susceptibility for diclofenac liver injury among women than men. The injury can be severe, and several cases of acute liver failure have been attributed to diclofenac.

Likelihood score: A (well known cause of clinically apparent liver injury).

Topical forms of diclofenac (solutions, gels, creams, patches) have been associated with only a low rate of serum enzyme elevations (generally less than 1%) that may be no greater than occurs with placebo or vehicle application. However, product labels for topical diclofenac mention the possibility of liver injury and several cases of clinically apparent liver injury attributed to topical diclofenac have been reported in the literature although the diagnosis in these cases have often been questionable. Thus, if clinically apparent liver injury due to topical forms of diclofenac occurs, it must be exceedingly rare.

### Histopathology

Diclofenac hepatotoxicity is typically associated with an acute hepatitis-like histology with necrosis that may be most prominent in zone 3 (centrally). There is usually focal necrosis and inflammation, but with severe cases the injury can be confluent or submassive. Chronic hepatitis-like injury with prominence of portal inflammation, interface hepatitis and fibrosis can be found, particularly in cases with longer latency and more prolonged course. A minority of cases showed mixed hepatocellular cholestatic injury (cholestatic hepatitis) with varying degrees of inflammation. Three photomicrographs are shown.

| Zone 3 necrosis. The hepatocytes around the vein (V) have been lost and replaced by an inflammatory infiltrate composed of lymphocytes and plasma cells.
| In this portal area there is a dense inflammatory infiltrate composed of lymphocytes, plasma cells and scattered eosinophils. There is marked interface hepatitis.
| Confluent bridging necrosis extending between two portal areas and involving zone 3. The bile ducts (arrows) and hepatic vein (V) mark the involved structures. Interface hepatitis is present around the edge of the residual hepatocyte parenchyma.

### Mechanism of Injury

The mechanism of diclofenac induced liver injury appears to be multifactorial, and the cause of mild serum aminotransferase elevations may be different from the cause of serious liver injury. An immuno-allergic component is suggested by the rapid and acute recurrence of injury, even many years after initial exposure and injury. Genetic studies have suggested a linkage with allelic variants of UGT 2B7, CYP 2C8 and ABC C2, which are genes involved the metabolism, conjugation and excretion of diclofenac.

### Outcome and Management

Severity of the liver injury ranges from asymptomatic elevations in serum aminotransferase levels (Cases 1 and 2), to overt icteric hepatitis (Case 3), acute liver failure and even death (Case 4). Complete recovery is expected after stopping the drug and usually takes 1 to 3 months. In rare instances, evidence of chronic liver injury persists, some of which have led to courses of corticosteroid therapy which appeared to be beneficial and could later be stopped without recurrence of liver injury. Acute liver failure following rechallenge after episodes of clinically apparent diclofenac hepatotoxicity has been reported and should be avoided. There is little evidence of cross sensitivity to hepatic injury between diclofenac and NSAIDs belonging to other classes, such as the propionic acids (ibuprofen, naproxen, ketoprofen), but few instances documenting safety have been reported and patients should be carefully monitored if switched to another NSAID.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Elevations in serum aminotransferase levels during first month of diclofenac therapy.(1)

A woman in her 30s with ankylosing spondylitis was started on diclofenac in a dose of 75 mg twice daily. One week later, although asymptomatic, she was found to have raised serum aminotransferase levels and the drug was discontinued. Viral and autoimmune hepatitis serologies were negative. Ultrasound was normal. During the following month, her ALT levels returned to baseline. She had previously tolerated ibuprofen and nabumetone without difficulty.

#### Key Points

Medication: | Diclofenac 75 mg orally twice daily
Pattern: | Hepatocellular (R=9)
Severity: | 1+ (never jaundiced, never hospitalized)
Latency: | Several days
Recovery: | Complete recovery 1 month after stopping the medication
Other medications: | Ibuprofen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Pre | | 49
0 | | | | | Diclofenac started
7 days | | 255 | 79 | 0.7
9 days | | 253
10 days | 0 | | | | Diclofenac stopped
16 days | 6 days | 275 | 84 | 0.5
4 weeks | 17 days | 71 | 89 | 0.4
6 weeks | 1 month | 37 | 73 | 0.3
Normal Values | | <42 | <115 | <1.2

#### Comment

Mild and transient increases in serum aminotransferase levels occur commonly in patients given diclofenac. These elevations are usually transient and may resolve even with continuation of the medication. Because they are associated with few if any symptoms, these elevations will go undetected in patients who are not routinely monitored. In this case, diclofenac was discontinued when repeat testing confirmed the abnormalities found on routine testing. Serum aminotransferase levels fell to normal within a few weeks. If there were no other therapeutic options, diclofenac might be restarted with careful monitoring with prompt discontinuation if ALT levels rise more than five-fold or if any symptoms or jaundice arise. She previously tolerated an NSAID belonging to a different class--ibuprofen (propionic acid).

### Case 2. Asymptomatic elevations in serum aminotransferase levels during long-term diclofenac therapy.(2)

A woman in her early 40s with a history of chronic knee pain was treated with diclofenac in a dose of 50 mg thrice daily. Approximately 5 months after starting diclofenac, she complained of a new onset of sharp, intermittent right upper quadrant pain and itching of the lower extremities and was found to have elevated serum aminotransferase levels on routine lab work. She denied fever, nausea, weight loss or jaundice. Tests for hepatitis A, B and C were negative, but antinuclear antibodies were strongly positive. Without change in medications, serum aminotransferase levels fluctuated, but she remained mildly symptomatic. Several months later, a liver biopsy was done which was consistent with chronic hepatitis of moderate-to-severe activity with mild periportal fibrosis. The patient was also taking atorvastatin, which was discontinued on the basis of its possible role in causing the aminotransferase elevations. Despite this, ALT levels remained elevated. Subsequently, diclofenac was discontinued and both aminotransferase elevations and her abdominal pain resolved promptly.

#### Key Points

Medication: | Diclofenac
Pattern: | Hepatocellular (R=8)
Severity: | 1+ (never jaundiced, never hospitalized)
Latency: | 5 months
Recovery: | Complete recovery within 3 months
Other medications: | Atorvastatin, ibuprofen, fexofenadine, rabeprazole, propranolol, synthroid, triamterene, hydrochlorothiazide, sumatriptan, glucosamine, chondroitin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | | | | Diclofenac started
5 months | | 332 | 126 | 0.5 | Itching, RUQ pain
7.5 months | | 68 | 110 | 0.4
9 months | | 430 | | | Biopsy, atorvastatin stopped
16 months | 0 | 250 | 119 | 0.5 | Diclofenac stopped
19 months | 3 months | 29 | 93 | 0.7
Normal Values | | <42 | <115 | <1.2

#### Comment

The association of serum aminotransferase elevations and diclofenac is supported by the resolution of the abnormalities once the medication was stopped. The nonspecific symptoms, presence of antinuclear antibody and fibrosis found on liver biopsy argue for stopping diclofenac and against rechallenge. Use of other NSAIDs should be done with caution, avoiding agents in the same class as diclofenac (acetic acid derivatives) such as indomethacin, sulindac and etodolac.

### Case 3. Severe acute hepatitis and liver failure due to diclofenac.(3)

A woman in her 60s with osteoarthritis of the hip was placed on the combination of diclofenac 50 mg and misoprostol (Arthrotec) by mouth three times daily. After 3 months, she complained of dark urine, epigastric pain and itching, and the medication was stopped. One week later, she developed worsening fatigue, hypersomnia, and jaundice and was hospitalized. Viral and autoimmune hepatitis serologies were negative. Ultrasound was negative. Abdominal CT showed fatty infiltration of the liver. The patient continued to deteriorate as her albumin levels dropped and she developed peripheral edema. However, she subsequently began to improve spontaneously. Symptoms and jaundice resolved after two months, and all liver tests were normal four months after onset.

#### Key Points

Medication: | Diclofenac 50 mg thrice daily
Pattern: | Hepatocellular (R=30)
Severity: | 4+ (jaundice and signs of hepatic failure)
Latency: | 3 months
Recovery: | Complete recovery in 4 months
Other medications: | Conjugated estrogen, synthroid, furosemide

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | | | | Diclofenac started
80 days | | | | | Pain, itching, jaundice
3 months | 0 | | | | Diclofenac stopped
| 10 days | 1829 | 168 | 13.0 | Herpetiform rash
| 12 days | 1514 | 137 | 16.4
| 2 weeks | 1201 | 130 | 16.5 | Hospitalized
| 3 weeks | 454 | 161 | 26.2
4 months | 4 weeks | 178 | 127 | 18.5 | Edema, albumin=1.9
| 5 weeks | 99 | 146 | 10.4
5 months | 2 months | 45 | 116 | 5.2 | Asymptomatic
8 months | 4 months | 22 | 77 | 1.0
11 months | 7 months | 15 | 56 | 0.8
Normal Values | | <42 | <115 | <1.2

#### Comment

This patient developed jaundice and severe liver injury after taking diclofenac for 3 months. She had signs of hepatic failure (rising INR and falling albumin), but ultimately recovered. She should be warned against further exposure to diclofenac; NSAIDs belonging to other classes (such as ibuprofen, ketoprofen, naproxen) are likely to be tolerated, but monitoring for aminotransferase elevations during the first months of therapy would be appropriate.

### Case 4. Acute liver failure and death due to diclofenac.(4)

A 65 year old woman with osteoarthritis developed the sudden onset of nausea, vomiting and fatigue six weeks after starting diclofenac 75 mg by mouth twice daily (having replaced ibuprofen therapy). Serum aminotransferase levels were minimally elevated (ALT 53 U/L, AST 40 U/L), having been normal 3 weeks earlier. Diclofenac was stopped and she was monitored. Five days later she was noted to be jaundiced and serum aminotransferase levels had risen precipitously (Table). She was treated with prednisone (30 mg daily), but continued to worsen and was admitted for evaluation. Her other medications included furosemide (20 mg daily) and famotidine (40 mg daily). She did not drink alcohol and had no history of liver disease or risk factors for viral hepatitis. On examination, she was jaundiced and lethargic. There was bilateral pitting edema, ascites and marked asterixis. Laboratory tests showed a total serum bilirubin of 36 mg/dL, ALT 140 U/L, AST 177 U/L and prothrombin time 15.8 seconds. Abdominal ultrasound showed a small liver with patent hepatic veins and no evidence of biliary obstruction. Tests for hepatitis A and B were negative as were autoantibodies. She subsequently had progressive hepatic failure and died 2 weeks after admission. Autopsy showed a shrunken liver with massive necrosis and severe cholestasis.

#### Key Points

Medication: | Diclofenac 75 mg twice daily
Pattern: | Hepatocellular (R=unable to calculate)
Severity: | 5+ (acute liver failure and death)
Latency: | 6 weeks
Recovery: | None
Other medications: | Furosemide, famotidine, prednisone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Bilirubin (mg/dL) | Comments
3 weeks | | Normal | Normal | Normal | Diclofenac started
6 weeks | 0 | 53 | 40 | | Nausea. Diclofenac stopped
7 weeks | 5 days | | 3750 | 17.0 | Prednisone started
8 weeks | 14 days | 140 | 177 | 36.0 | Ascites and asterixis
10 weeks | 28 days | | | | Died of liver failure
Normal Values | | <45 | < 45 | <1.2

#### Comment

A dramatic example of precipitous drug induced acute liver failure. Diclofenac was discontinued promptly upon appearance of symptoms of fatigue and nausea, at which time serum aminotransferase levels were only mildly elevated. Despite this, the patient developed jaundice and marked aminotransferase elevations a few days later, and subsequently, showed signs of acute liver failure and died 3 weeks after onset of jaundice and 4 weeks after stopping diclofenac. The lack of cross reactivity to hepatic injury is suggested by the history of tolerance of ibuprofen (a propionic acid NSAID).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Diclofenac – Cataflam®, Voltaren®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=diclofenac)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Diclofenac | 15307-86-5 | C14-H11-C12-N-O2

## CITED REFERENCES

1 A case in the database of the Drug-Induced Liver Injury Network
2 A case in the database of the Drug-Induced Liver Injury Network
3 A case in the database of the Drug-Induced Liver Injury Network
4 Helfgott SM, Sandberg-Cook J, Zakim D, Nestler J. Diclofenac-associated hepatotoxicity. JAMA 1990; 264: 2660-2 2232043

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2025

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. The NSAIDS. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-41. (Review of hepatotoxicity of NSAIDs published in 1999 mentions that more than 60 cases of diclofenac hepatotoxicity have been appeared in the literature and 180 were known to the FDA; clinical features resemble acute hepatitis with hepatocellular enzyme elevations; a disproportional number of cases occur in women with osteoarthritis).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Expert review of liver injury caused by NSAIDs mentions that diclofenac has been implicated in more than 250 cases of hepatocellular damage with a case fatality rate of ~10%; metabolic idiosyncrasy is suspected to be the cause).
Grossner T, Smyth EM, Fitzgerald GA. Anti-inflammatory, antipyretic, and analgesic agents: pharmacotherapy of gout. In, Brunton LL, Chabner BA, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 959-1004. (Textbook of pharmacology and therapeutics).
Ciccolunghi SN, Chaudri HA, Schubiger BI, Reddrop R. Report on a long-term tolerability study of up to two years with diclofenac sodium(Voltaren). Scand J Rheumatol Suppl 1978; 22: 86-96. 356251 (Among 286 patients treated with diclofenac, elevation in liver tests in occurred in 38 [13%] and was reason for stopping therapy in 2 [1%]; no mention of hepatitis or jaundice).
Dunk AA, Walt RP, Jenkins WJ, Sherlock SS. Diclofenac hepatitis. Br Med J(Clin Res Ed) 1982; 284: 1605-6. 6805622 (52 year old man developed jaundice 4 months after starting diclofenac [bilirubin 7.4 mg/dL, AST 1375 U/L] with partial resolution on stopping, but recurrence [bilirubin 11.8 mg/dL, AST 1150 U/L] on restarting drug, then resolving within 6 weeks).
Babany G, Pessayre D, Benhamou JP. [Hepatitis caused by diclofenac] Gastroenterol Clin Biol 1983; 7: 316. French. 6852419 (60 year old man developed abdominal pain, fever, rash and jaundice 6 months after starting diclofenac [bilirubin 2.4 mg/dL, ALT 31 times ULN, Alk P 1.6 times ULN, no eosinophilia], resolving within 2 months of stopping).
Deshayes P, Leloet X, Bercoff E, Fouin-Fortunet H. [Diclofenac hepatitis. A case] Presse Med 1984; 13: 1847. French. 6236451 (72 year old woman developed jaundice 12 weeks after starting diclofenac [bilirubin 4.4 mg/dL, ALT 7 times ULN, Alk P 3 times ULN], resolving in 8 weeks of stopping).
Lascar G, Grippon P, Lévy VG. [Acute fatal hepatitis during treatment with diclofenac(Voltarène)] Gastroenterol Clin Biol 1984; 8: 881-2. French. 6526249 (55 year old woman developed jaundice and confusion 3 weeks after a 2 week course of diclofenac suppositories [bilirubin 12.6 mg/dL, ALT 937 U/L, Alk P 466 U/L], with subsequent progression to acute liver failure and death within 14 days).
Babany G, Bernuau J, Danan G, Rueff B, Benhamou JP. [Fulminating hepatitis in a woman taking glafenine and diclofenac] Gastroenterol Clin Biol 1985; 9: 185. French. 2858427 (45 year old woman developed jaundice 2 months after starting diclofenac and glafenine [another NSAID like diclofenac], with bilirubin 7.9 mg/dL, ALT 30 times ULN and with progression to fulminant hepatic failure and death; both diclofenac and glafenine have been linked to cases of acute liver failure).
Paret Masana A, Guarga Rojas A, Urrutia de Diego A, Sabriá Leal M. [Acute hepatitis and diclofenac sodium] Rev Clin Esp 1986; 179: 476. Spanish. 3809683 (42 year old woman developed fatigue, nausea and fever one week after starting diclofenac [bilirubin 4 mg/dL, ALT 915 U/L, Alk P 435 U/L, eosinophils 4%], with rapid recovery after stopping and similar recurrence upon rechallenge).
Breen EG, McNicholl J, Cosgrove E, McCabe J, Stevens FM. Fatal hepatitis associated with diclofenac. Gut. 1986; 27:1390-3. 3792922 (56 year old man developed jaundice, rash and fever 11 weeks after starting diclofenac [bilirubin 6.7 mg/dL, ALT 2210 U/L, Alk P 321 U/L], with progression to acute liver failure and death 24 days later; autopsy showed massive necrosis).
Schapira D, Bassan L, Nahir AM, Scharf Y. Diclofenac-induced hepatotoxicity. Postgrad Med J. 1986; 62: 63-5. 3797366 (Two case reports; 68 year old woman developed jaundice and rash within 14 days of starting diclofenac and recurrence in 7 days of rechallenge [bilirubin 5.2 mg/dL, AST 90 U/L, Alk P 274 U/L], resolving within 2 months of stopping; 70 year old woman developed (rash and jaundice 5 days after starting diclofenac [bilirubin 4.8 mg/dL, AST 100 U/L, Alk P 173 U/L], resolving 1 month after stopping).
Snijder RJ, Dinant HJ, Stricker BH. [Fatal liver damage during use of diclofenac] Ned Tijdschr Geneeskd 1987; 131: 2088-90. Dutch. 3683638 (21 year old woman with systemic lupus erythematosus on hydroxychloroquine developed jaundice 2 weeks after starting diclofenac [bilirubin 9.5 mg/dL, ALT 1113 U/L, Alk P 269 U/L], which was continued until 1 week later when she was admitted with acute liver failure, dying 4 days afterwards).
Llorca G, Larbre JP, Collet Ph, Ravault A, Lejeune E. Changing the class of NSAID in cases of hepatotoxicity. Ann Rheum Dis 1988; 791. 3178321 (44 year old man developed eosinophilia and mild elevations in Alk P [144 U/L], with normal ALT and bilirubin and no symptoms 2 months after starting diclofenac, resolving rapidly upon stopping and not recurring when he was given ketoprofen). 3178321
Hovette P, Touze JE, Debonne JM, Delmarre B, Rogier C, Schmoor P, et al. [Cholestatic hepatitis and acute kidney insufficiency during treatment with diclofenac] Ann Gastroenterol Hepatol(Paris) 1989; 25: 257-8. French. 2619253 (66 year old woman developed abdominal pain, fever and rash 8 days after starting diclofenac [eosinophils 2%, direct bilirubin 1.6, ALT 4 times ULN, Alk P 8 times ULN and oliguria with creatinine 11.4 mg/dL], rapid recovery on stopping).
Mazeika PK, Ford MJ. Chronic active hepatitis associated with diclofenac sodium therapy. Br J Clin Pract 1989; 43: 125-6. 2611118 (40 year old woman developed jaundice 6 months after starting to take diclofenac [bilirubin 6.0 mg/dL, ALT 970 U/L, Alk P 209 U/L], improving symptomatically upon stopping, but ALT remained elevated and flared to 500 U/L 16 months later [ANA negative, biopsy showing chronic hepatitis], responding to prednisone).
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. 2281340 (Extensive review article on liver injury due to NSAIDs; diclofenac associated with minor ALT elevations in 15% of treated patients, and rarely with clinically apparent acute hepatocellular or mixed injury with a latency of 1-6 months, mechanism clearly idiosyncrasy, either metabolic or immunologic).
Helfgott SM, Sandberg-Cook J, Zakim D, Nestler J. Diclofenac-associated hepatotoxicity. JAMA 1990; 264: 2660-2. 2232043 (7 cases of diclofenac hepatoxicity; latency of 5 to 20 weeks, bilirubin 1.0 to 40.5 mg/dL, ALT 252 to 2409 U/L, Alk P 55 to 360 U/L, 6 with symptoms, 3 with jaundice, one died of hepatic failure: Case 4).
Iveson TJ, Ryley NG, Kelly PM, Trowell JM, McGee JO, Chapman RW. Diclofenac associated hepatitis. J Hepatol 1990; 10: 85-9. 2307831 (5 cases of diclofenac hepatotoxicity from a single center; latencies 3, 6, 6, 10 and 44 weeks; bilirubin 10.4, 18.4, 0.9, 22.0 and 0.6 mg/dL; AST 1328, 1056, 145, 1385 and 332 U/L; Alk P 819, 1214, 295, 654 and 414 to U/L; recovery in 4-12 weeks in 4 and persistence at 12 months with chronic hepatitis in one; all ANA negative).
Sallie R. Diclofenac hepatitis. J Hepatol. 1990; 11: 281. 2254638 (Letter in response to Iveson [1990] mentioning cases ultimately described in 1991 Aust NZ J Med article).
Purcell P, Henry D, Melville G. Diclofenac hepatitis. Gut 1991; 32: 1381-5. 1752473 (Review of liver adverse drug reactions due to diclofenac from Australia, 26 cases considered probable, 15 with jaundice, 4 fatal, hepatocellular pattern of enzymes).
Ouellette GS, Slitzky BE, Gates JA, Lagarde S, West AB. Reversible hepatitis associated with diclofenac. J Clin Gastroenterol 1991; 13: 205-10. 2033230 (74 year old woman developed jaundice 6 months after starting diclofenac [bilirubin 10.6 mg/dL, ALT 1210 U/L, Alk P 523 U/L], resolving within 3 months of stopping).
Sallie RW, McKenzie T, Reed WD, Quinlan MF, Shilkin KB. Diclofenac hepatitis. Aust N Z J Med 1991; 21: 251-5. 1872757 (5 cases of jaundice arising after 6-20 weeks of diclofenac therapy [bilirubin 1.8 to 30.4 mg/dL, AST 148 to 634 U/L, Alk P 149 to 548 U/L], resolving within 2-4 months; 2 with ANA; one with persistent injury for 4 months after stopping, treated with prednisone with ultimate resolution even after dicontinuing corticosteroids).
Adebajo AO, Eastmond CJ. Hepatotoxicity to several nonsteroidal anti-inflammatory drugs with diclofenac induced histological changes. Clin Rheumatol 1992; 11: 120-1. 1582111 (44 year old woman had mild ALT elevations on naproxen that resolved; found to have elevated values after 4 months of diclofenac [bilirubin 1.1 mg/dL, AST 271 U/L, Alk P 130 U/L] which resolved rapidly with stopping, but recurred after 3 months of tiaprofenic acid; showing cross reactivity to various NSAIDs).
Nos P, Palau J, Pérez-Aguilar F, Berenguer J. [Hepatitis associated with taking diclofenac] Rev Esp Enferm Dig 1992; 81: 367. Spanish. 1616747 (69 year old woman developed jaundice 4 months after starting diclofenac [bilirubin 22.5 mg/dL, ALT 2960 U/L, Alk P 343 U/L], resolving rapidly [20 days] upon stopping).
Selz F, Cereda JM. [Fatal sub-fulminant hepatitis due to diclofenac] Rev Med Suisse Romande 1993; 113: 985-7. French. 8290850 (65 year old woman developed jaundice 9 days after starting diclofenac [bilirubin 12.7 mg/dL, ALT 2200 U/L, Alk P 245 U/L], progressing to hepatic failure and death within 3 weeks, autopsy showing massive necrosis and collapse; review of 6 previously reported cases of acute liver failure due to diclofenac).
Scully LJ, Clarke D, Barr RJ. Diclofenac induced hepatitis. 3 cases with features of autoimmune chronic active hepatitis. Dig Dis Sci 1993; 38: 744-51. 8462374 (3 women with diclofenac hepatotoxicity with autoimmune features [ages 48, 57 and 69 years] arising 8-16 weeks after starting drug; bilirubin normal in 2, 15.4 mg/dL in 1; AST 59, 299 and 1970 U/L; Alk P normal in 2, and 234 U/L in one; ANA 1:40 to 1:640, resolving in 4-8 weeks of stopping; recurred with tiaprofenic acid, but not with naproxen).
Garcia Rodriguez LA, Williams R, Derby LE, Dean AD, Jick H. Acute liver injury associated with nonsteroidal anti-inflammatory drugs and the role of risk factors. Arch Intern Med 1994; 154: 311-6. 8297198 (Retrospective cohort study of cases of acute liver injury in England after exposure to NSAIDs; 23 cases – none fatal – including 5 from ibuprofen, 4 diclofenac, 4 naproxen, 2 mefenamic acid, 3 ketoprofen, 2 piroxicam, 2 fenbuten and 3 sulindac).
Ramakrishna B, Viswanath N. Diclofenac-induced hepatitis: case report and literature review. Liver 1994; 14: 83-4. 8196514 (53 year old woman had 2 episodes of jaundice after use of diclofenac with latency of 7 and then 3 weeks, bilirubin 17.8 mg/dL, ALT 862 U/L, Alk P 622 U/L, no eosinophilia or rash, ANA equivocal, recovery in 2 months).
Banks AT, Zimmerman HJ, Ishak KG, Harter JG. Diclofenac-associated hepatotoxicity: analysis of 180 cases reported to the Food and Drug Administration as adverse reactions. Hepatology 1995; 22: 820-7. 7657288 (Summary analysis of 180 cases of diclofenac hepatotoxicity reported to FDA during 3 year period; 67% symptomatic, 50% jaundiced; 8% mortality in patients with jaundice; latency 1-6 months in 85% of cases; hepatocellular enzyme pattern in most).
Zaragoza Marcet A, Alfonso Moreno V, Roig Catala E. [NSAID-induced hepatotoxicity: aceclofenac and diclofenac] Rev Esp Enferm Dig 1995; 87: 472-5. Spanish. 7612373 (64 year old man developed fatigue after 14 days and jaundice after 20 days of diclofenac therapy [bilirubin 12.6 mg/dL, ALT 87 U/L, Alk P 474 U/L], resolving within 4 weeks of stopping; second case due to aceclofenac).
Hernández Beriain J, Segura García C. [Aceclofenac-induced hepatitis] Rev Esp Enferm Dig 1995; 87: 550-1. Spanish. 7662428 (90 year old woman developed jaundice 7 days after switching from indomethacin to aceclofenac [an NSAID similar to diclofenac], with bilirubin 5.6 mg/dL, ALT 561 U/L, Alk P 640 U/L and rapid recovery [20 days] upon stopping).
Pérez Moreno JM, Puertas Montenegro M, Fernández Ruiz A, Fernández González MA. [Toxic hepatitis caused by aceclofenac] Rev Esp Enferm Dig 1996; 88: 815-6. Spanish. 9004792 (37 year old man developed abdominal pain and nausea 2 weeks after starting aceclofenac [bilirubin 2.5 mg/dL, ALT 550 U/L, Alk P 333 U/L], resolving rapidly, complete within 3 months.
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. 9041931 (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs was ~10 cases per 100,000 patient-years of use, ranging from 6 to 18 per 100,000 for diclofenac [based upon 6 cases in all]).
Prieto de Paula JM, Romero Castro R, Villamandos Nicás YV. [Hepatic toxicity caused by aceclofenac] Gastroenterol Hepatol 1997; 20: 165. Spanish. 9162542 (39 year old woman developed asymptomatic elevations in ALT [279 U/L], GGT [84 U/L], but no jaundice [bilirubin 1.4 mg/dL] 1 month after starting aceclofenac, an NSAID similar to diclofenac, resolving within 2 months of stopping).
Vilà Santasuana A, Cid Pañella R, Roure Nuez C, Martínez Montauti J, Ortega Enciso YL. [Acute hepatitis caused by diclofenac] Gastroenterol Hepatol 1997; 20: 164-5. Spanish. 9162541 (29 year old woman developed abdominal pain within 2 days and fever and jaundice within 5 days of starting diclofenac [bilirubin 5.1 mg/dL, ALT 3988 U/L, Alk P 128 U/L], resolving rapidly within 2 weeks upon stopping).
Hackstein H, Mohl W, Püschel W, Stallmach A, Zeitz M. [Diclofenac-associated acute cholestatis hepatitis] Z Gastroenterol 1998; 36: 385-9. German. 9654706 (64 year old man developed jaundice 3 weeks after starting diclofenac following spinal surgery and isoflurane anesthesia [bilirubin 18.4 mg/dL, ALT 215 U/L, Alk P 1594 U/L], resolving over next 4 months; no mention of antibiotic use at time of surgery).
Bhogaraju A, Nazeer S, Al-Baghdadi Y, Rahman M, Wrestler F, Patel N. Diclofenac-associated hepatitis. South Med J 1999; 92: 711-3. 10414481 (58 year old developed symptoms after 4 and jaundice after 5 weeks of diclofenac therapy [bilirubin 17 mg/dL, ALT 1503 U/L, Alk P 170 U/L, 9% eosinophils, protime 16 sec and ascites], but resolving within 6 weeks of stopping).
Pérez-Gutthann S, García-Rodríguez LA, Duque-Oliart A, Varas-Lorenzo C. Low-dose diclofenac, naproxen, and ibuprofen cohort study. Pharmacotherapy 1999; 19: 854-9. 10417034 (Analysis of database of general practice in UK on 3 million persons followed between 1991 and 1995, including 22,146 patients receiving first prescription for diclofenac, 46,919 naproxen and 54,830 ibuprofen in "low" doses [typical of over-the-counter use] found 64 patients with complications, including 13 with liver injury, but only 3 of which could be confirmed: 1 due to naproxen [0.2/10,000], 2 ibuprofen [0.4/10,000], none diclofenac).
Dierkes-Globisch A, Schäfer R, Mohr HH. [Asymptomatic diclofenac-induced acute hepatitis] Dtsch Med Wochenschr 2000; 125: 797-800. German. 10916496 (49 year old man developed jaundice 4 weeks after starting diclofenac [bilirubin 2.5 mg/dL, ALT 1591 U/L, Alk P 244 U/L, ANA 1:160], resolving within 9 weeks of stopping).
Fernández-Avala Novo M, Penado Nadela S, Nan Nan DN, González Macías J. [Toxic hepatitis caused by aceclofenac] Rev Clin Esp 2001; 201: 616-7. Spanish. 11817238 (69 year old woman developed jaundice 1 week after starting aceclofenac [an NSAID similar to diclofenac] with bilirubin 32 mg/dL, ALT 1097 U/L, Alk P 808 U/L, and recovery within 3 months of stopping).
Traversa G, Bianchi C, Da Cas R, Abraha I, Menniti-Ippolito F, Venegoni M. Cohort study of hepatotoxicity associated with nimesulide and other non-steroidal anti-inflammatory drugs. BMJ 2003; 327: 18-22. 12842950 (Among 397,537 patients who received a prescription for an NSAID [770,000 person years] between 1997 and 2002, 42 developed an acute nonviral hepatitis [30 per 100,000] including 8 receiving diclofenac, one fatal).
Boelsterli UA. Diclofenac-induced liver injury: a paradigm of idiosyncratic drug toxicity. Toxicol Appl Pharmacol 2003; 192: 307-22. 14575648 (Review of possible etiology of liver injury due to diclofenac including toxic intermediates, mitochondrial injury, immunogenic adducts and aberrant transport).
Aithal GP. Diclofenac-induced liver injury: a paradigm of idiosyncratic drug toxicity. Expert Opin Drug Saf 2004; 3: 519-23. 15500411 (Editorial and review of mechanism of liver injury by diclofenac, including aberrant metabolism by CYP 2C9, formation of adducts and immune responses or adduct antibodies).
Aithal GP, Ramsay L, Daly AK, Sonchit N, Leathart JB, Alexander G, et al. Hepatic adducts, circulating antibodies, and cytokine polymorphisms in patients with diclofenac hepatotoxicity. Hepatology 2004; 39: 1430-40. 15122773 (Antibodies to diclofenac liver protein adducts found in all 7 patients with diclofenac hepatotoxicity, in 12 of 20 without injury and no healthy controls, similar adducts found in autopsy from fatal case; also detected increase in variant alleles for IL-10 and IL-4 patients with diclofenac hepatotoxicity).
de Abajo FJ, Montero D, Madurga M, Garcia Rodriguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. 15206996 (Analysis of General Practice Research Database of 1.6 million people in UK 1994-2000 found 128 cases of drug induced liver injury; 10 due to diclofenac which occurred most commonly in women, receiving higher doses and longer durations of treatment).
Lacroix I, Lapeyre-Mestre M, Bagheri H, et al; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie (CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. 15066135 (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France found 88 cases which were compared to 178 controls; 22 cases vs 16 controls had been exposed to NSAIDs; 5 diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen and 1 meloxicam).
Rubenstein JH, Laine L. Systematic review: the hepatotoxicity of non-steroidal anti-inflammatory drugs. Aliment Pharmacol Ther 2004; 20: 373-80. 15298630 (NSAIDs are the most commonly used drugs in the US and account for a large proportion of cases of hepatic injury, but the frequency is quite rare. Among 7 population based studies, hospitalization occurred in 22.4/100,000 patient-years of diclofenac exposure [rate ratio 1.5]; rate did not increase with age and was not associated with gender; in case controlled studies, higher odds ratio of liver injury occurred with sulindac, indomethacin, piroxicam and diclofenac).
Roth SH, Shainhouse JZ. Efficacy and safety of a topical diclofenac solution (pennsaid) in the treatment of primary osteoarthritis of the knee: a randomized, double-blind, vehicle-controlled clinical trial. Arch Intern Med 2004; 164: 2017-23. 15477437 (Among 326 patients with osteoarthritis treated with topical diclofenac or placebo four times daily for 12 weeks, major side effects were dry skin and rash; ALT levels were not monitored and there was no mention of clinically apparent liver injury).
Tugwell PS, Wells GA, Shainhouse JZ. Equivalence study of a topical diclofenac solution (pennsaid) compared with oral diclofenac in symptomatic treatment of osteoarthritis of the knee: a randomized controlled trial. J Rheumatol 2004; 31: 2002-12. 15468367 (Among 622 patients with osteoarthritis treated with oral vs topical diclofenac for 12 weeks, changes in pain and dysfunction scores were similar, but ALT elevations occurred more often with oral than topical therapy [any elevation 17% vs 5%; above 3 times ULN in 4.7% vs 1.1%]).
Rostom A, Goldkind L, Laine L. Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol 2005; 3: 489-98. 15880319 (Review of randomized clinical trials of NSAIDS for frequency of adverse events; ALT values above 3 times ULN occurred in 0.43% of patients exposed to ibuprofen, 0.43% naproxen, 0.42% celecoxib, 1.8% rofecoxib, 3.55% diclofenac and 0.29% placebo; liver related serious adverse events were rare and no liver related deaths were reported).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroentero 2005; 40: 1095-101. 16165719 (Review of 103 cases of fatal drug induced liver injury from Sweden between 1966 and 2002; most common causes were halothane [16], acetaminophen [14], flucloxacillin [9], sulfonamides [9], and diclofenac [3]; during same period there were 120 reports of nonfatal diclofenac liver injury).
Bjornsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. 16054882 (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; diclofenac ranked 15th with 56 cases and was the only NSAID in the top 20 causes).
De Valle MB, Av Klinteberg V, Alem N, Olsson R, Björnsson E. Drug-induced liver injury in a Swedish University hospital out-patient hepatology clinic. Aliment Pharmacol Ther 2006; 24: 1187-95. 17014577 (Among 1164 patients with liver disease seen over a 10 year period at a single Swedish referral center, 77 [6.6%] were suspected due to drug induced liver injury; 56% women; mean age 58 years, 48% hepatocellular, 40% cholestatic; antibiotics were most common, followed by NSAIDs, the most common of which was diclofenac [14 cases, 6 jaundiced]).
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20:391-5. 16867024 (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; relative risk raised for droxicam, sulindac, nimesulide, and clometacin; minimally raised for naproxen, diclofenac, piroxicam and tenoxicam).
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verma A, et al. Use of cyclo-oxygenase 2 inhibitors(COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. 17086563 (Survey of NSAID use in UK and USA indicates ibuprofen, naproxen and diclofenac are the most commonly used; diclofenac more frequently outside of US).
Sanchez-Matienzo D, Arana A, Castellsague J, Perez-Gutthann S. Hepatic disorders in patients treated with COX-2 selective inhibitors or nonselective NSAIDs: a case/noncase analysis of spontaneous reports. Clin Ther 2006; 28: 1123-32. 16982289 (Review of FDA Medwatch reports of adverse events: 158,539 received, 3% liver related; higher proportion liver adverse events for sulindac, diclofenac and nimesulide; not for other Cox-2 inhibitors).
Watanabe N, Takashimizu S, Kojima S, Kagawa T, Nishizaki Y, Mine T, et al. Clinical and pathological features of a prolonged type of acute intrahepatic cholestasis. Hepatol Res 2007; 37: 598-607. 17517076 (Discussion of histological findings in two cases of diclofenac induced prolonged cholestasis showing bile duct loss and relative absence of MRP2 staining compared to self-limited cases).
Daly AK, Aithal GP, Leathart JB, Swainsbury RA, Dang TS, Day CP. Genetic susceptibility to diclofenac-induced hepatotoxicity: contribution of UGT2B7, CYP2C8, and ABCC2 genotypes. Gastroenterology 2007; 132: 272-81. 17241877 (Genotyping of UGT2B7, CYP2C8 and ABCC2 done on 24 patients with diclofenac hepatotoxicity and controls, found allelic variants that correlated with occurrence of injury).
Laine L, Goldkind L, Curtis SP, Connors LG, Yanqiong Z, Cannon CP. How common is diclofenac-associated liver injury? Analysis of 17,289 arthritis patients in a long-term prospective clinical trial. Am J Gastroenterol 2009; 104: 356-62. 19174782 (Examination of a clinical trial database of diclofenac vs etoricoxib in 34,701 patients with arthritis; ALT elevations above 3 times ULN occurred in 3.1% and above 10 times in 0.5% of diclofenac treated patients [vs 0.7% and 0.05% for etoricoxib], leading to discontinuation in 2.5% and hospitalization for liver injury and jaundice in 0.023% [16 per 100,000 patient-years], but no deaths).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. 15390328 (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to diclofenac).
Oaks JL, Gilbert M, Virani MZ, Watson RT, Meteyer CU, Rideout BA, Shivaprasad HL, et al. Diclofenac residues as the cause of vulture population decline in Pakistan. Nature 2004; 427: 630-3. 14745453 (A marked decline in population of Oriental white backed vultures occurred in the 1990s later shown to be due to acute renal failure and severe hyperuricemia caused by feeding on diclofenac treated livestock).
Andrade RJ, Lucena MI, Fernandez MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. 16083708 (Reports of drug induced liver injury to a Spanish network found 570 cases, diclofenac ranked 7th with 12 cases, 10 hepatocellular, none fatal).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, Guarner C, Forné M, Solà R, Castellote J, Rigau J, Laporte JR. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25:1401-9. 17539979 (Population based survey of 126 cases of acute drug induced liver injury in Spain between 1993-1999 calculated relative risk of injury compared to the general population as 7.6 for diclofenac [n=8], with estimated incidence of 2.9 per 100,000 patient-years).
Aithal GP, Day CP. Nonsteroidal anti-inflammatory drug-induced hepatotoxicity. Clin Liver Dis 2007; 11: 563-75, vi-vii. 17723920 (Review of hepatotoxicity of NSAIDs focusing upon mechanisms of injury).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. 18955056 (Among 300 cases of drug induced liver disease in the US between 2004 and 2008, more than 100 agents were implicated including diclofenac [n=4], ranking 13th in frequency).
Yerly G, Cereda JM. Severe hepatitis due to percutaneous diclofenac. Gastroenterol Clin Biol 2008; 32: 824-5. 18818036 (52 year old woman with primary biliary cirrhosis developed jaundice shortly after use of percutaneous diclofenac for back pain [bilirubin 10.8 mg/dL, ALT 2012 U/L, Alk P 123 U/L], with decrease of liver test abnormalities to her baseline [ALT 103 U/L, Alk P 82 U/L] over the following 6 months).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. 20648003 (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; 8 [2.6%] were attributed to NSAIDs including 1 to diclofenac].
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. PubMed Citation (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; diclofenac is the most widely used NSAID and its likelihood of causing liver injury varied considerably in different reports in the literature). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. 20949552 (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 7 to NSAIDs, including 4 to bromfenac, 2 diclofenac and 1 etodolac, but none to ketoprofen, ibuprofen or naproxen).
Roth SH, Fuller P. Diclofenac topical solution compared with oral diclofenac: a pooled safety analysis. J Pain Res 2011; 4: 159-67. 21811391 (Combined analysis of safety in two 12 week controlled trials of oral vs topical diclofenac in 927 patients with osteoarthritis of the knee; ALT elevations were more frequent with oral [rising from 9.5% at baseline to 22% at 12 weeks] compared to topical diclofenac [10.9% to 10.4%], but no patient developed clinically apparent liver injury and only one discontinued therapy early because of liver enzyme elevations).
Cuthbert R, Taggart MA, Prakash V, Saini M, Swarup D, Upreti S, Mateo R, Chakraborty SS, Deori P, Green RE. Effectiveness of action in India to reduce exposure of Gyps vultures to the toxic veterinary drug diclofenac. PLoS One 2011; 6: e19069. 21589920 (Surveys of prevalence of diclofenac in carcases of ungulates [mostly cattle] in India before and after a public ban on its use in veterinary medicine showed a 40% decrease [10-11% to 6%], but need for further efforts).
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. 21263458 (Review of drug induced liver injury due to rheumatologic agents mentions that most diclofenac cases present within 6 months [85%] and only rarely after one year [3%], usually with a hepatocellular pattern of enzyme elevations, the etiology likely to be multifactorial).
Anelli MG, Scioscia C, Grattagliano I, Lapadula G. Old and new antirheumatic drugs and the risk of hepatotoxicity. Ther Drug Monit 2012; 34: 622-8. 23128910 (Review of drug induced liver injury due to rheumatologic agents including diclofenac).
Hawkins MT, Lewis JH. Latest advances in predicting DILI in human subjects: focus on biomarkers. Expert Opin Drug Metab Toxicol 2012; 8: 1521-30. 22998122 (Review of the status of biomarkers for prediction of drug induced liver injury).
Lee CH, Wang JD, Chen PC; Health Data Analysis in Taiwan (hDATa) Research Group. Case-crossover design: an alternative strategy for detecting drug-induced liver injury. J Clin Epidemiol 2012; 65: 560-7. 22445086 (Analysis of National Health Insurance database for Taiwan for risk of hospitalization for liver injury within 30 days of taking a medication, found an adjusted odds ratio for taking diclofenac of 2.6-2.9 compared to 24.4-29.3 for isoniazid).
Nezic L, Krähenbühl S, Rätz Bravo AE. [Diclofenac induced liver injuries]. Praxis (Bern 1994) 2012; 101: 371-9. German. 22419135 (Abstract only; 83 year old woman developed self-limited liver injury within 9 days of starting diclofenac).
Peniston JH, Gold MS, Wieman MS, Alwine LK. Long-term tolerability of topical diclofenac sodium 1% gel for osteoarthritis in seniors and patients with comorbidities. Clin Interv Aging 2012; 7: 517-23. 23204844 (Among 947 patients treated with topical diclofenac for osteoarthritis for up to one year, none developed clinically apparent liver injury; ALT monitoring was not done).
Baraf HS, Gold MS, Petruschke RA, Wieman MS. Tolerability of topical diclofenac sodium 1% gel for osteoarthritis in seniors and patients with comorbidities. Am J Geriatr Pharmacother 2012; 10: 47-60. 22264852 (Analysis of 5 placebo controlled trials of topical diclofenac for 8-12 weeks for knee and hand osteoarthritis found ALT elevations in 0.1-0.3% of diclofenac vs 0.3-0.5% of placebo recipients).
Roth SH, Fuller P. Diclofenac sodium topical solution 1.5% w/w with dimethyl sulfoxide compared with placebo for the treatment of osteoarthritis: pooled safety results. Postgrad Med 2011; 123: 180-8. 22104466 (Analysis of safety data of topical diclofenac in 1252 patients with osteoarthritis in 7 placebo controlled trials found no change in average ALT or AST levels with either diclofenac or placebo, and a slight increase in average GGT levels in both groups [by 1.5 and 1.6 U/L]).
Shainhouse JZ, Grierson LM, Naseer Z. A long-term, open-label study to confirm the safety of topical diclofenac solution containing dimethyl sulfoxide in the treatment of the osteoarthritic knee. Am J Ther 2010; 17: 566-76. 20216203 (Among 793 patients with osteoarthritis treated with topical diclofenac for 2 to 455 days, serum ALT levels rose above normal in 7.3% [maximal change: 29 to 211 U/L], but no patient developed clinically apparent liver injury).
Pillans PI, Ghiculescu RA, Lampe G, Wilson R, Wong R, Macdonald GA. Severe acute liver injury associated with lumiracoxib. J Gastroenterol Hepatol 2012; 27: 1102-5. 22142375 (Three cases of liver injury due to lumiracoxib, a selective COX-2 inhibitor that was not approved for use in the US and was withdrawn from use elsewhere because of hepatotoxicity; 49, 52, and 63 year old Australian women with osteoarthritis developed jaundice 3, 6 and 6 months after starting lumiracoxib [bilirubin 4.7, 16.0 and 17.5 mg/dL, ALT 652, 1180 and 3016 U/L, Alk P 344, 393 and 754 U/L, all 3 ANA positive], one dying, one undergoing liver transplant and one recovering but with persistent liver injury and cirrhosis).
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. 23325533 (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset, including acetaminophen in 192 and NSAIDs in 44, including diclofenac [the most commonly used NSAID] in 7 for a rate of 1.55 per million-treatment years).
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Association Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. 21929527 (Analysis of serious adverse events reporting to a French pharmacovigilance data found highest cumulative rates for liver related reports for nimesulide [0.15 per million defined daily doses], followed by diclofenac [0.09], ketoprofen [0.09], piroxicam [0.06], naproxen [0.04] and meloxicam [0.03] being significant in case/noncase analyses for nimesulide, diclofenac and piroxicam only).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. 23419359 (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd] for an estimated incidence of ~1 per 9,000 persons exposed).
Unzueta A, Vargas HE. Nonsteroidal anti-inflammatory drug-induced hepatoxicity. Clin Liver Dis 2013; 17: 643-56, ix. 24099022 (Review of hepatotoxicity of NSAIDs mentions that more than 5 million prescriptions for diclofenac are filled yearly in the US and the rate of severe hepatotoxicity is relatively low, although fatalities have been reported).
Fok KC, Bell CJ, Read RB, Eckstein RP, Jones BE. Lumiracoxib-induced cholestatic liver injury. Intern Med J 2013; 43: 731-2. 23745998 (83 year old woman developed serum enzyme elevations 7 months after starting lumiracoxib for osteoarthritis, with gradual rise thereafter [bilirubin not given, ALT 208 U/L, Alk P 1174 U/L, GGT 2114 U/L], ultimately resolving after lumiracoxib was stopped, but timing of events and specific details not provided).
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. 24918129 (Among 82 patients with suspected drug induced liver injury seen at a single Turkish referral center between 2008 and 2012, 19 were attributed to NSAIDs [23%], most commonly diclofenac [n=8, 10%], one case resulting in death).
deLemos AS, Foureau DM, Jacobs C, Ahrens W, Russo MW, Bonkovsky HL. Drug-induced liver injury with autoimmune features. Semin Liver Dis 2014; 34: 194-204. 24879983 (Review of drug induced liver injury with autoimmune features).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. 24552865 (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 2 of which were attributed to diclofenac, one of which was fatal).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, diclofenac was the 9th most frequent cause of drug induced liver injury and was implicated in 15 cases [1.7%], one of which was fatal).
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. 26601797 (Among 1221 cases of drug induced liver injury enrolled in a prospective US registry, 30 were attributed to NSAIDs, 16 [1.3%] of which were due to diclofenac, including 10 with jaundice, 5 scored as severe and one fatal; all cases were hepatocellular and latency ranged from 6 days to 6 months, 4 with immunoallergic and 6 with autoimmune features; initial mean ALT 1386 U/L, Alk P 182 U/L, bilirubin 8.0 mg/dL).
Petros Z, Makonnen E, Aklillu E. Genome-wide association studies for idiosyncratic drug-induced hepatotoxicity: looking back-looking forward to next-generation innovation. OMICS 2017; 21: 123-31. 28253087 (Review of genetic studies of drug induced liver injury mentions that diclofenac hepatotoxicity has been linked to polymorphisms of UGT2B7 and ABCC2, but these associations have not been reported with genome-wide studies).
Ramachandran A, Visschers RGJ, Duan L, Akakpo JY, Jaeschke H. Mitochondrial dysfunction as a mechanism of drug-induced hepatotoxicity: current understanding and future perspectives. J Clin Transl Res. 2018;4:75-100. 30873497. (Review of data on drug induced mitochondrial injury focusing upon acetaminophen but also mentioning that diclofenac induced hepatic mitochondrial dysfunction by several mechanisms including loss of mitochondrial membrane potential and altering its permeability transition).
Daniels AM, Gibbs LM, Herndon CM. Elevated transaminases with topical diclofenac: A case report. J Pain Palliat Care Pharmacother. 2018;32:161-164. 30645151. (79 year old woman was found to have elevations in ALT [104 U/L] and AST [118 U/L] at the time of a routine annual follow up visit for breast cancer that arose while taking 10 medications including topical diclofenac [1% gel applied 4 times daily for 10 months] which improved on stopping and worsened again on restarting but never became normal and AST averaged being twice as elevated as ALT; no mention of alcohol use)
Teschke R. Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. 2018;14:1169-1187. 30354694. (In a review of 3312 published cases of drug-induced liver injury using RUCAM to define causality, diclofenac ranked 5th in frequency with 46 cases).
Björnsson ES, Medina-Caliz I, Andrade RJ, Lucena MI. Setting up criteria for drug-induced autoimmune-like hepatitis through a systematic analysis of published reports. Hepatol Commun. 2022;6:1895-1909. 35596597. (Review of 186 case reports of acute autoimmune-like hepatitis caused by drugs including 7 attributed to diclofenac with latencies of 1 to 4 months, 6 with ANA and 3 with SMA positivity, all with biopsy features of autoimmune injury, and the 4 treated with corticosteroids tolerated discontinuation without relapse).
Delungahawatta T, Pokharel A, Paz R, Haas CJ. Topical diclofenac-induced hepatotoxicity. J Community Hosp Intern Med Perspect. 2023;13:108-112. 37877052. (94 year old man hospitalized after an accidental fall was found to have abnormal liver tests [bilirubin 4.9 mg/dL, ALT 239 U/L, AST 426 U/L, Alk P 368 U/L, CPK 5549 U/L and INR 1.8] which resolved with 3 weeks of stopping topical diclofenac which had been started 4 months previously).
Barritt AS 4th, Hayashi PH, Stolz AA, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network (DILIN). Refinement of Hy Law Using the Drug-Induced Liver Injury Network Database. Am J Gastroenterol. 2024 Oct 18: Epub ahead of print. 39422332. (Among 1718 cases of drug induced liver injury enrolled in a U.S. prospective study between 2004 and 2021, diclofenac ranked 11th as a cause of jaundice accounting for 20 cases which were mostly hepatocellular, but only one of which was fatal). 39422332
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-Update with genetic correlations. Liver Int. 2024;44:1409-1421. 38451034. (Among 55 cases of liver injury attributed to an NSAID enrolled in a US database between 2004 and 2022, 29 [53%] were attributed to diclofenac, which was associated with a HLA-DRB1*04.03 carrier frequency [CF] of 7% [n=4/29] compared to a population AF of 0.7%).
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. 38913369. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications, at a rate of 1 per 12,500 patients exposed to diclofenac).
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 23 cases of due to diclofenac which was estimated as an incidence of 1 per 4,800 persons treated).
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 49 were attributed to NSAIDs, including 19 [4%] to diclofenac [63% women, mean age 55, 63% female, 63% hepatocellular, none fatal]). 38992407
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2025;23:1061-1062.e1. 39447947. (Analysis of a health database of 16 Indiana University Health hospitals, identified 54 cases of drug-induced liver injury including 3 attributed to diclofenac which was estimated to be 1 per 7,037 treated).

## OTHER REFERENCE LINKS

1. Recent References on Diclofenac: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Diclofenac/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

2. Trials on Diclofenac: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Diclofenac)